# Trabectedin

## OVERVIEW

### Introduction

Trabectedin is a natural product derived from the Caribbean sea squirt which has antineoplastic activity and is used to treat soft tissue sarcoma. Trabectedin therapy is associated with a high rate of transient serum enzyme elevations during treatment and with occasional instances of clinically apparent liver injury with jaundice.

### Background

Trabectedin (tra bek' te din) is a novel antineoplastic agent initially derived from extracts of the Caribbean sea squirt, Ecteinascidia turbinata or mangrove tunicate. It was the first drug to be isolated from a sea animal. Trabectedin binds to the minor groove of DNA, allowing for alkylation of guanine and resulting in DNA damage. Biosynthesis of the active product allowed for clinical trials of trabectedin which demonstrated evidence of cytotoxic activity against soft tissue sarcomas. Trabectedin was approved for use in the United States in 2014 as therapy of advanced, refractory liposarcoma and leiomyosarcoma. Trabectedin is given intravenously and is available as 1 mg of lyophilized powder in single use vials under the brand name Yondelis. The typical dose is 1.5 mg/m^2^ body surface area as a 24 hour infusion every 3 weeks. It is usually given after premedication with 20 mg of dexamethasone. Side effects are common and include bone marrow suppression, nausea, vomiting, diarrhea, anorexia, fatigue, peripheral edema, dyspnea, and headache. Serious adverse events include neutropenic sepsis, rhabdomyolysis, cardiomyopathy, capillary leak syndrome, and embryo-fetal toxicity. Lurbinectedin, a synthetic derivative of trabectedin with similar antineoplastic activity and adverse event profile, was approved for use in small cell lung cancer in 2020.

### Hepatotoxicity

Elevations in serum aminotransferase levels arise in almost all patients treated with trabectedin and elevations above 5 times the upper limit of normal occur 20% to 50% of patients. Pretreatment with dexamethasone appears to decrease the degree and frequency of enzyme elevations. The elevations arise within 2 to 5 days of the intravenous infusion, rise to maximal levels between 5 and 9 days and generally fall to baseline values within 3 to 4 weeks. Minor elevations in serum alkaline phosphatase and bilirubin are also common. However, clinically apparent liver injury with jaundice from trabectedin is rare. On the other hand, patients with underlying liver disease appear to be at increased risk for septicemia and multiorgan failure, and monitoring of liver tests before and during therapy is recommended. The liver injury typically mimics acute decompensation of an underlying cirrhosis with modest elevations in serum enzymes and worsening jaundice and hepatic synthetic dysfunction. Immunoallergic and autoimmune features are uncommon. Fatalities are generally due to sepsis and multiorgan failure.

Likelihood score: C[HD] (probable cause of clinically apparent liver injury, generally in the setting of preexisting liver disease and use of high doses).

### Mechanism of Injury

The transient serum aminotransferase elevations that occur with trabectedin therapy are most likely due to direct hepatotoxicity. Trabectedin is extensively metabolized by the hepatic cytochrome P450 system, predominantly CYP 3A4, and is susceptible to drug-drug interactions with agents that induce or inhibit CYP 3A activity.

### Outcome and Management

The severity of liver injury from trabectedin ranges from mild elevations in liver enzymes to marked aminotransferase elevations to clinically apparent liver injury with jaundice and hepatic failure. Most severe cases occur in patients with preexisting liver disease. For these reasons, patients should be monitored with routine liver tests before and during therapy and therapy delayed or stopped if liver test abnormalities persist. In animal models, hepatotoxicity is lessened by pretreatment with dexamethasone and pretreatment with 20 mg of dexamethasone 30 minutes before each infusion is recommended.

Drug Class: Antineoplastic Agents, Alkylating Agents

Other Drugs in Same Class: Lurbinectedin

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Trabectedin – Yondelis®

DRUG CLASS

Antineoplastic Agents, Alkylating Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Trabectedin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Trabectedin | 114899-77-3 | C39-H43-N3-O11-S

## ANNOTATED BIBLIOGRAPHY

References updated: 22 November 2022

Zimmerman HJ. Oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 673-708. (Expert review of hepatotoxicity of cancer chemotherapeutic agents published in 1999 before the availability of trabectedin).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 541-68. (Review of hepatotoxicity of cancer chemotherapeutic agents; trabectedin is listed as causing serum enzyme elevations and rare instances of liver failure when given in high doses).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Trabectedin. Cytotoxic agents. Chemotherapy of neoplastic diseases. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1194. (Textbook of pharmacology and therapeutics).
Brain EG. (2002). Safety and efficacy of ET-743: the French experience. Anticancer Drugs. (Among 54 patients with advanced, refractory soft tissue sarcoma treated with trabectedin [1500 μg/m^2^ intravenously every 3 weeks], 3 [6%] had a partial response, and side effects included asymptomatic and reversible neutropenia and aminotransferase elevations in 60% of patients and 2 cases of rhabdomyolysis).
van Kesteren Ch, de Vooght MMM, López-Lázaro L, Mathôt RA, Schellens JH, Jimeno JM, Beijnen JH. (2003). Yondelis (trabectedin, ET-743): the development of an anticancer agent of marine origin. Anticancer Drugs. (Review of the development, chemistry, mode of action and preclinical and clinical studies of trabectedin suggests that it acts by binding to the minor groove of DNA, thereby interfering with transcription factor binding to DNA and blocking transcription).
Yovine A, Riofrio M, Blay JY, Brain E, Alexandre J, Kahatt C, Taamma A, et al. (2004). Phase II study of ecteinascidin-743 in advanced pretreated soft tissue sarcoma patients. J Clin Oncol. (Among 54 patients with advanced, refractory soft tissue sarcoma treated with trabectedin [1-20 cycles], 6 had a partial or minor response, and side effects included ALT or AST elevations above 5 times ULN in 50% of patients with 2 treatment related deaths, one from rhabdomyolysis and one from febrile neutropenia which resulted in decompensation of a preexisting alcoholic cirrhosis).
Beumer JH, Schellens JH, Beijnen JH. (2005). Hepatotoxicity and metabolism of trabectedin: a literature review. Pharmacol Res. (Review of trabectedin hepatotoxicity in preclinical and clinical studies; mentions that hepatotoxicity is seen in mice, rats, dogs, and rhesus monkeys and is partially abrogated by dexamethasone pretreatment; the ALT elevations in humans start to rise 2-5 days after an infusion, reach at maximum at 5-9 days, and resolve within 4 weeks, the abnormalities often lessening with repeated cycles).
Le Cesne A, Blay JY, Judson I, Van Oosterom A, Verweij J, Radford J, Lorigan P, et al. (2005). Phase II study of ET-743 in advanced soft tissue sarcomas: a European Organisation for the Research and Treatment of Cancer (EORTC) soft tissue and bone sarcoma group trial. J Clin Oncol. (Among 104 patients with soft tissue or bone sarcoma treated with trabectedin [1500 mg/m^2^ every 3 weeks], ALT elevations above 5 times ULN arose in 45%, bilirubin elevations in 42%, Alk P in 63% and neutropenia in 52%, while 4 patients died usually of multiorgan failure, but correlating best with preexisting liver abnormalities, particularly any elevation in Alk P).
Grosso F, Dileo P, Sanfilippo R, Stacchiotti S, Bertulli R, Piovesan C, Jimeno J, et al. (2006). Steroid premedication markedly reduces liver and bone marrow toxicity of trabectedin in advanced sarcoma. Eur J Cancer. (Among 54 patients with advanced, refractory sarcomas treated with trabectedin, 31 did and 23 did not receive pretreatment with oral dexamethasone [4 mg twice daily for the 24 hours before infusions], and adverse events were less with pretreatment including aminotransferase elevations [above 5 times ULN] in 2% vs 34%, neutropenia in 2% vs 24% and thrombocytopenia in none vs 25%, while objective response rates and progression free survival appeared unaffected).
Krasner CN, McMeekin DS, Chan S, Braly PS, Renshaw FG, Kaye S, Provencher DM, et al. (2007). A Phase II study of trabectedin single agent in patients with recurrent ovarian cancer previously treated with platinum-based regimens. Br J Cancer. (Among 147 women with recurrent ovarian carcinoma after platinum based therapy who were treated with trabectedin [0.58 mg/m^2^ every week], ALT elevations occurred in 28% and were above 5 times ULN in 11%, but all were self-limited in course).
Demetri GD, Chawla SP, von Mehren M, Ritch P, Baker LH, Blay JY, Hande KR, et al. (2009). Efficacy and safety of trabectedin in patients with advanced or metastatic liposarcoma or leiomyosarcoma after failure of prior anthracyclines and ifosfamide: results of a randomized phase II study of two different schedules. J Clin Oncol. (Among 270 patients with advanced or metastatic, refractory soft tissue sarcoma treated with 1 of 2 regimens of trabectedin [weekly or every 3rd week], response rates were higher with every 3 week dosing as were adverse events including ALT elevations above 5 times ULN [45% vs 9%], but there were no instances of hepatic failure).
Pick AM, Nystrom KK. (2010). Fatal hepatic and renal toxicity as a complication of trabectedin therapy for radiation-induced sarcoma. J Oncol Pharm Pract. (79 year old man with sarcoma developed progressive renal and hepatic failure 1 week after a 2nd [every 3 weeks] intravenous infusion of trabectedin [bilirubin initially 2.4 and rising to 12 mg/dL, ALT 73 to 502 U/L, Alk P 473 U/L] and dying 3 weeks later [no autopsy]).
Fayette J, Boyle H, Chabaud S, Favier B, Engel C, Cassier P, Thiesse P, et al. (2010). Efficacy of trabectedin for advanced sarcomas in clinical trials versus compassionate use programs: analysis of 92 patients treated in a single institution. Anticancer Drugs. (Among 92 patients with advanced sarcoma treated with trabectedin [1.5 mg/m^2^ every 3 weeks], adverse events included ALT or AST elevations above 5 times ULN in 37%, but no “toxic deaths” occurred).
Le Cesne A, Yovine A, Blay JY, Delaloge S, Maki RG, Misset JL, et al. (2012). A retrospective pooled analysis of trabectedin safety in 1,132 patients with solid tumors treated in phase II clinical trials. Invest New Drugs. (Among 1132 patients treated with trabectedin in various regimens in 19 trials, common side effects including nausea [65%], fatigue [58%], neutropenia [69%], ALT elevations [91%], ALT elevations above 5 times ULN [44%] and bilirubin elevations [21%]).
Baruchel S, Pappo A, Krailo M, Baker KS, Wu B, Villaluna D, Lee-Scott M, et al. (2012). A phase 2 trial of trabectedin in children with recurrent rhabdomyosarcoma, Ewing sarcoma and non-rhabdomyosarcoma soft tissue sarcomas: a report from the Children's Oncology Group. Eur J Cancer. (Among 50 children with recurrent sarcomas who were treated with trabectedin [1.3 or 1.5 mg/m^2^ every 3 weeks], only one patient had a partial response and 3 others had stable disease, while adverse events were common including ALT elevations above 5 times ULN in 32%, but all were asymptomatic and resolved without dose adjustment).
Monk BJ, Blessing JA, Street DG, Muller CY, Burke JJ, Hensley ML. (2012). A phase II evaluation of trabectedin in the treatment of advanced, persistent, or recurrent uterine leiomyosarcoma: a gynecologic oncology group study. Gynecol Oncol. (Among 20 women with advanced uterine leiomyosarcoma treated with 2-29 cycles of trabectedin, the progression free survival rate was 5.8 months and adverse events included ALT elevations in 55% which were above 5 times ULN in 10%).
Laurenty AP, Thomas F, Chatelut E, Bétrian S, Le Guellec C, Hennebelle I, Le Guellec S, et al. (2013). Irreversible hepatotoxicity after administration of trabectedin to a pleiomorphic sarcoma patient with a rare ABCC2 polymorphism: a case report. Pharmacogenomics. (66 year old man with pleiomorphic sarcoma developed liver injury 3 weeks after a second infusion of trabectedin [bilirubin 0.5 mg/dL, ALT 7 times ULN, Alk P 5 times ULN], with subsequent slow rise of bilirubin to 9.5 mg/dL and persistently high Alk P], liver biopsy showing cholangitis and jaundice persisting until his death from metastatic sarcoma 10 months later).
Ploner F, Lamm W, Schur S, Eisterer W, Kühr T, Lindorfer A, Tinchon C, et al. (2013). The Austrian experience with trabectedin in non-selected patients with metastatic soft tissue sarcoma (STS). J Cancer Res Clin Oncol. (Among 101 adult Austrian patients with metastatic soft tissue sarcoma treated with trabectedin, the extent and severity of toxicity “were low and manageable”, including ALT elevations in 25% with values above 5 times ULN in 3%).
Samuels BL, Chawla S, Patel S, von Mehren M, Hamm J, Kaiser PE, Schuetze S, et al. (2013). Clinical outcomes and safety with trabectedin therapy in patients with advanced soft tissue sarcomas following failure of prior chemotherapy: results of a worldwide expanded access program study. Ann Oncol. (Among 1895 adults with advanced soft tissue sarcomas treated with trabectedin [1.5 mg/m^2^ every 3 weeks], best results were achieved in leiomyosarcoma and liposarcoma, while ALT elevations arose in 19% and were above 5 times ULN in 11%; no mention of clinically apparent liver injury, although 23 patients [1%] died of suspected drug related complications).
Vincenzi B, Stumbo L, Maltese G, Cerbone L, Spalato Ceruso M, Badalamenti G, Santini D, et al. (2015). Lack of correlation between liver tests abnormalities and trabectedin efficacy in the treatment of soft tissue sarcoma: a retrospective study. Sci Rep. (Among 113 patients with advanced sarcoma treated with trabectedin in 3 Italian oncology centers, 40% developed ALT or AST elevations above 5 times ULN, and retrospective analyses found no associations between ALT elevations and tumor response or progression free or overall survival).
Bui-Nguyen B, Butrynski JE, Penel N, Blay JY, Isambert N, Milhem M, Kerst JM, et al. (2015). European Organisation for Research and Treatment of Cancer Soft Tissue and Bone Sarcoma Group (EORTC/STBSG) and the Sarcoma Alliance for Research through Collaboration (SARC). A phase IIb multicentre study comparing the efficacy of trabectedin to doxorubicin in patients with advanced or metastatic untreated soft tissue sarcoma: the TRUSTS trial. Eur J Cancer. (Among 133 patients with soft tissue sarcoma treated with trabectedin [as 3 or 24 hour infusions] vs doxorubicin [standard therapy], median progression free survival was less with trabectedin [2.8 and 3.1 vs 5.5 months] and side effects were more common, requiring discontinuation in 15% and 20% vs 3% and with ALT elevations above 5 times ULN in 67% and 49% vs 2.5%]).
Kawai A, Araki N, Sugiura H, Ueda T, Yonemoto T, Takahashi M, Morioka H, et al. (2015). Trabectedin monotherapy after standard chemotherapy versus best supportive care in patients with advanced, translocation-related sarcoma: a randomised, open-label, phase 2 study. Lancet Oncol. (Among 76 Japanese patients with advanced sarcoma treated with trabectedin [1.2 mg/m^2^ every 3 weeks] vs supportive case, median progression-free survival was 5.6 vs 0.9 months and adverse events included nausea [89% vs 8%], anorexia [53% vs 5%], neutropenia [83% vs 0%] and elevated ALT [67% vs 0%]).
Schack LH, Mouritsen LS, Elowsson C, Krarup-Hansen A, Safwat A. (2015). The Danish experience with trabectedin treatment for metastatic sarcoma: Importance of hyponatremia. Acta Oncol. (Among 117 patients with metastatic sarcoma treated with trabectedin in 3 oncology centers in Denmark, adverse events were frequent including 22% with “elevated liver enzymes” and there were 3 deaths, all related to severe infections).
Martin-Broto J, Pousa AL, de Las Peñas R, García Del Muro X, Gutierrez A, Martinez-Trufero J, Cruz J, et al. (2016). Randomized phase II study of trabectedin and doxorubicin compared with doxorubicin alone as first-line treatment in patients with advanced soft tissue sarcomas: a Spanish group for research on sarcoma study. J Clin Oncol. (Among 115 patients with soft tissue sarcoma treated with doxorubicin with or without trabectedin [1.1 mg/m^2^ every 3 weeks], progression-free survival was minimally longer with the combination [5.7 vs 5.5 months] and adverse events were more frequent including ALT elevations [71% vs 14%] and those greater than 5 times ULN [19% vs none]).
(2016). In brief: Two drugs for soft-tissue sarcoma. Med Lett Drugs Ther. (Concise summary of the mechanism of action, efficacy and safety of trabectedin and eribulin shortly after their approval in the US as therapy of soft tissue sarcoma; mentions that trabectedin therapy is associated with serum aminotransferase elevations).
Demetri GD, von Mehren M, Jones RL, Hensley ML, Schuetze SM, Staddon A, Milhem M, et al. (2016). Efficacy and safety of trabectedin or dacarbazine for metastatic liposarcoma or leiomyosarcoma after failure of conventional chemotherapy: results of a phase III randomized multicenter clinical trial. J Clin Oncol. (Among 518 patients with metastatic lipo- or leiomyosarcoma treated with trabectedin vs dacarbazine, progression-free survival was longer with trabectedin [4.2 vs 1.5 months], but overall survival similar [12.4 vs 12.9 months], while ALT elevations arose in 45% vs 6% and were above 5 times ULN in 26% vs 1%).
Angarita FA, Cannell AJ, Abdul Razak AR, Dickson BC, Blackstein ME. (2016). Trabectedin for inoperable or recurrent soft tissue sarcoma in adult patients: a retrospective cohort study. BMC Cancer. (Among 77 adults with advanced soft tissue sarcoma treated with trabectedin, elevations in liver enzymes occurred in 26% of subjects including values above 5 times ULN in 19%, but there were no serious liver related adverse events and two deaths attributed to therapy were both due to rhabdomyolysis).
Barone A, Chi DC, Theoret MR, Chen H, He K, Kufrin D, Helms WS, et al. (2017). FDA approval summary: trabectedin for unresectable or metastatic liposarcoma or leiomyosarcoma following an anthracycline-containing regimen. Clin Cancer Res. (FDA description of the clinical results of trabectedin therapy that led to its approval for soft tissue sarcomas in 2015, which was based upon a single, randomized active controlled trial in 518 patients in which median progression-free survival was 4.2 months with trabectedin vs 1.5 months with dacarbazine; serious adverse events included anaphylaxis, neutropenic sepsis, rhabdomyolysis, hepatotoxicity, cardiomyopathy and local tissue necrosis from extravasation during intravenous therapy).
Kobayashi H, Iwata S, Wakamatsu T, Hayakawa K, Yonemoto T, Wasa J, Oka H, et al. (2020). Efficacy and safety of trabectedin for patients with unresectable and relapsed soft-tissue sarcoma in Japan: A Japanese Musculoskeletal Oncology Group study. Cancer. (Among 140 Japanese patients with soft tissue sarcomas treated with trabectedin [1.2 mg/m^2^ every 3 weeks] and enrolled in a postmarketing study of safety, 96% had an adverse event, and ALT or AST elevations arose in 89 [64%] which were above 5 times ULN in 53 [38%], but there were no deaths from liver failure).
Palmerini E, Sanfilippo R, Grignani G, Buonadonna A, Romanini A, Badalamenti G, Ferraresi V, et al. (2021). Trabectedin for patients with advanced soft tissue sarcoma: a non-interventional, retrospective, multicenter study of the Italian Sarcoma Group. Cancers (Basel). (Among 512 patients with advanced soft tissue sarcoma treated with trabectedin in 20 Italian centers, median survival was 21.6 months and adverse events included bone marrow toxicity in 61% and ALT or AST elevations in 22%, but there were no deaths attributed to therapy and no mention of clinically apparent liver injury).
Cortinovis D, Grosso F, Carlucci L, Zucali PA, Pasello G, Tiseo M, Sperandi F, et al., ATREUS investigators. (2021). Trabectedin in malignant pleural mesothelioma: results from the multicentre, single arm, phase II ATREUS Study. Clin Lung Cancer. (Among 132 patients with malignant pleural mesothelioma treated with trabectedin [1.1 or 1.3 mg/m^2^ intravenously every 3 weeks], the clinical efficacy was described as “modest” and “at the expense of relevant liver toxicity”, with ALT or AST elevations above 5 times ULN arising in 59% of patients and contributing to death from multiorgan failure in one).
Le Cesne A, Blay JY, Cupissol D, Italiano A, Delcambre C, Penel N, Isambert N, et al. (2021). A randomized phase III trial comparing trabectedin to best supportive care in patients with pre-treated soft tissue sarcoma: T-SAR, a French Sarcoma Group trial. Ann Oncol. (Among 103 patients with advanced soft tissue sarcoma treated with trabectedin or standard therapy in 16 French centers, the median progression-free survival was longer with trabectedin [3.1 vs 1. 5 months], and 33% of patients developed ALT or AST elevations above 5 times ULN, although there were no deaths due to liver injury and no mention of clinically apparent liver injury ).
Lorusso D, Pignata S, Tamberi S, Mangili G, Bologna A, Nicoloso MS, Giolitto S, et al. Efficacy and safety of trabectedin for the treatment of advanced uterine or ovarian carcinosarcoma: Results of a phase II multicenter clinical trial (MITO-26). Gynecol Oncol. 2022:S0090-8258(22)01851-0. Epub ahead of print. (Among 45 women with advanced refractory ovarian or uterine carcinoma treated with trabectedin [1.3 mg/m^2^ every 3 weeks], the objective response rate was only 12% and ALT or AST elevations above 3 times ULN arose in 14%, none rising above 5 times ULN and all ultimately resolving).
Chaigneau L, Jary M, Nerich V, Hervieu A, Aubry S, Charon Barra C, Meynard G, et al. (2022). Real-world experience of efficacy and safety of trabectedin in patients with soft tissue sarcoma: a bicentric retrospective analysis. Oncology. (Among 126 patients with advanced soft tissue sarcoma treated with trabectedin in 2 French centers between 2002 and 2019, overall median survival was 12.3 months with disease control in 46% of patients, while “adverse events were manageable”, GGT elevations arising in 83% [above 5 times ULN in 27%], and with 4 deaths due to therapy, 3 with rhabdomyolysis and 1 with febrile neutropenia).

## OTHER REFERENCE LINKS

1 Recent References on Trabectedin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Trabectedin/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Trabectedin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Trabectedin)